# Senna

## OVERVIEW

### Introduction

Senna (Cassia species) is a popular herbal laxative that is available without prescription. Senna is generally safe and well tolerated, but can cause adverse events including clinically apparent liver injury when used in high doses for longer than recommended periods.

### Background

Senna (sen’ a) belongs to a large genus of flowering plants found throughout the tropics, commonly used species being Cassia acutifolia (Alexandrian senna) and C. angustifolio (Indian or Tinnevelly senna). Extracts of the leaves, flowers and fruit of senna have been used for centuries in folk medicine as a laxative and stimulant. Senna is also included in several herbal teas, used for purging and in weight loss. The active components in senna extracts are anthraquinone derivatives and their glucosides, referred to as senna glycosides or sennosides. The sennosides are not absorbed but are hydrolyzed by colonic bacteria releasing the active moieties, rhein and rhein-anthrone which appear to act as local irritants on the colon, promoting peristalsis and evacuation. Sennosides and their metabolites may also enhance intestinal fluid accumulation and increase the moisture content of stool by inhibiting electrolyte and water reabsorption and increasing chloride secretion from the colon. Senna is minimally absorbed. Senna is used in many over-the-counter laxatives in combination with other agents under trade names such as Ex-lax, Fletcher’s Castoria and Senokot. The typical dose is 15 to 30 mg of sennosides twice a day, but is recommended for short term use only (less than one week). Side effects include abdominal cramps and electrolyte imbalance. Long term use or abuse can lead to “cathartic” colon with diarrhea, cramps, weight loss and darkened pigmentation of the colonic mucosa.

### Hepatotoxicity

Use of senna in the recommended doses for a limited period of time has been associated with few side effects, most of which are mild and transient and related to its laxative action. With longer term and higher dose use of senna, however, adverse events have been described including several cases of clinically apparent liver injury. The time to onset of liver injury was usually after 3 to 5 months of use, and the pattern of serum enzyme elevations was hepatocellular. The liver injury was usually mild-to-moderate in severity and resolved rapidly with discontinuation. In at least one instance, reexposure led to rapid recurrence of liver injury. Immunoallergic features and autoimmune markers were not present in the published cases.

In addition, a related plant commonly known as coffee senna or Cassia orientalis has been linked to many instances of acute, severe toxicity with encephalopathy, myopathy and hepatic dysfunction. Outbreaks of “hepato-myo-encephopathy” of unknown cause among children occurred yearly in Uttar Pradesh, India typically between September and November. Investigation eventually identified Cassia occidentalis ingestion as the probable cause, typically occurring in children who eat the leaves or pods of the common flowering weed. While Cassia occidentalis has also been used to prepare tea, the amount ingested was minimal. In children, and rarely in adults, the presentation was precipitous with nausea, vomiting, tremor, abnormal and violent behavior, grimacing and self-mutilation followed by stupor and coma at which time serum aminotransferase and bilirubin levels were typically elevated. In severe instances, the liver injury was progressive, serum ammonia and INR levels rose and patients developed coma, convulsions and status epilepticus that was unresponsive to therapy. Autopsies revealed hepatic necrosis and cholestasis. A similar pattern of symptoms and injury occurs in animals that consume Cassia occidentalis. Whether this syndrome has a similar pathogenesis to the rare instance of hepatic injury attributed to typical senna (Cassia acutifolia or angustifolio) that is used as a laxative is unknown.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The liver injury due to senna has been attributed to the anthraquinone derivatives present in the herbal extract, and most cases have been associated with taking excessive doses suggesting a direct hepatotoxic rather than idiosyncratic etiology. Other anthraquinones used to treat constipation have been implicated in causing liver injury with long term use, including cascarosides (cascara) and hydroxyanthraquinone.

### Outcome and Management

Liver injury from long term senna use is rare, and most cases have been self-limited and rapidly reversible upon stopping the laxative. However, cases with a severe course with signs of acute liver failure have been described. There is no evidence of cross sensitivity to hepatic damage with other laxatives. Restarting senna after hepatotoxicity has been associated with recurrence of liver injury and should be avoided.

Drug Class: Herbal and Dietary Supplements

Other Drugs in the Subclass, Anthraquinones: Cascara

## CASE REPORT

### Case 1. Acute liver injury due to Senna [Cassia angustifolia].(1)

A 52 year old woman was developed anorexia and progressive weakness followed by confusion and jaundice, having used large amounts of tea prepared from dry senna products to treat chronic constipation for several years. On presentation she was confused, weak and mildly jaundiced. Blood testing revealed serum glucose of 40 mg/dL, bilirubin 6.2 mg/dL, ALT 9160 U/L, AST 6640 U/L, GGT 160 U/L and INR 5.7. She also had lactic acidosis and renal insufficiency. She was admitted to the intensive care unit and soon required ventilation. Her coagulopathy worsened and she developed polyuria and phosphate wasting. She received intensive support and after several days began to improve. She was discharged after a 3 week hospitalization and, when seen one month later, was asymptomatic and all laboratory tests had returned to normal. Tests for hepatitis A, B and C, for autoantibodies and for acetaminophen levels were not reported. The botanicals used for making tea were analyzed and found to represent Cassia angustifolio without metal or other contaminants.

#### Key Points

Medication: | Senna
Pattern: | Acute hepatic necrosis
Severity: | 4+ (severe with signs of hepatic failure)
Latency: | 3 years
Recovery: | Complete within one month
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Bilirubin (mg/dL) | INR | Other
3 years | 1 | 9160 | 6.2 | 5.7 | Admission
| 2 | 4000 | | 6.9 | Ventilation
| 3 | 2930 | | 2.9
| 5 | 825 | | 1.8
| 7 | 265 | | 1.5
| 9 | 95 | | 1.6
| 18 | 75 | | 0.9
Normal Values | | <34 | <1.2 | < 1.2

#### Comment

The sudden onset of hepatic failure, lactic acidosis and encephalopathy is characteristic of acute hepatic necrosis due to a direct toxin. In this instance, the patient had been taking an excessive about of senna over a prolonged period, and it was not clear what precipitated this acute decompensation. Possible explanations are that it was triggered by a coincidental infection or dehydration or a change in the formulation of the Senna product. The general features of this clinical case report resemble those of hepato-myo-encephalopathy described from India in children who consume the pods or fruit of Cassia occidentalis. Conventional senna used as a laxative is quite safe, but these reports suggest that an overdose can cause acute hepatic failure with early signs of encephalopathy.

### Case 2. Acute liver injury due to coffee senna [Cassia occidentalis].(2)

A 75 year old woman developed nausea, vomiting, diarrhea and low grade fever after medicating herself for two weeks with leaves of Senna occidentalis. She was seen at a local hospital and found to have a mildly elevated white blood cell count (12,000) with 80% neutrophils but normal serum bilirubin, ALT and alkaline phosphatase (Table). She was sent home but continued to worsen, developing confusion and jaundice and was admitted to a tertiary referral center 2 days later with stupor, deep jaundice and anasarca. Blood testing showed a serum bilirubin of 12.9 mg/dL (direct 10.4), ALT 130 U/L, Alk P 43 U/L, INR 2.68 and ammonia 127 µmol/L. Ultrasound revealed a normal sized liver and spleen and mild ascites. A lumbar puncture was normal. Tests for hepatitis A, B, C and E were negative. She was intubated and given antibiotics and fresh frozen plasma. She continued to deteriorate and developed coma, seizures, status epilepticus and died 2 days later, 5 days after her initial presentation.

#### Key Points

Medication: | Senna occidentalis leaves
Pattern: | Acute hepatic necrosis
Severity: | 5+ (fatal)
Latency: | 2 weeks
Recovery: | None
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0
2 weeks | 1 day | 42 | 105 | 0.8
| 3 days | 130 | 43 | 12.9 | INR 2.68 Stupor
| 5 days | 542 | 184 | 18.7 | Deep coma, death
Normal Values | | Not given | Not given | < 1.2

#### Comment

The sudden onset of nausea, vomiting and diarrhea followed shortly after by confusion, stupor and jaundice is typical of the syndrome of “hepato-myo-encephalopathy” described from India among children who consumed the fruit or pods of the common local weed Cassia occidentalis (coffee senna). This case was unusual in that it occurred in an adult and was not due to acute consumption but to several weeks of intake of the botanical as pain relief from chronic knee osteoarthritis. The liver injury is typical of acute hepatic necrosis or hyperacute liver failure with early signs of hepatic failure even when the bilirubin is normal or only mildly elevated. Hyperammonemia and coagulopathy arise early. This syndrome also has prominent neurologic signs and deaths are often due to encephalopathy rather than hepatic failure. The syndrome is not always fatal and, in some cases, intensive medical support appears to tide patients over the acute toxic effects. Recovery is rapid and seemingly complete. At issue is whether this syndrome is similar or related to the cases of acute liver injury that have been attributed to other Senna species such as Cassia angustifolia or acutifolia, which are used to produce the laxative commonly referred to as Senna (see Case 1).

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Senna – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://www.nlm.nih.gov/medlineplus/druginfo/natural/652.html)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Senna | 8013-11-4 | Herbal mixture

## CITED REFERENCES

1 Beuers U, Spengler U, Pape GR. (1991). Hepatitis after chronic abuse of senna. Lancet.
2 Ish P, Rathi S, Singh H, Anuradha S. (2019). Senna Occidentalis poisoning: an uncommon cause of liver failure. ACG Case Rep J.

## ANNOTATED BIBLIOGRAPHY

References updated: 01 April 2020

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; senna is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; senna is not discussed).
Senna. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 743-7. (Compilation of short monographs on herbal medications and dietary supplements).
Tolman KG, Hammar S, Sannella JJ. (1976). Possible hepatotoxicity of Doxidan. Ann Intern Med. (24 year old man developed fatigue 6 months after starting Doxidan [containing hydroxyanthraquinone for chronic constipation] and at 12 months developed nausea and syncope [bilirubin 0.8 mg/dL, AST 560 U/L, Alk P 339 U/L, ANA negative, slight neutropenia], liver biopsy showing chronic hepatitis, resolving within 1 month of stopping, recurring upon rechallenge).
Beuers U, Spengler U, Pape GR. (1991). Hepatitis after chronic abuse of senna. Lancet. (26 year old nurse taking high doses of senna alkaloids developed jaundice and pruritus [bilirubin not given, ALT 303 U/L, Alk P 227 U/L], resolving within a few weeks of stopping and recurring upon restarting [ALT >280 U/L]).
Franz G. (1993). The senna drug and its chemistry. Pharmacology. (Senna is dried leaflets or fruits of Cassia senna, either acutifolia [Alexandrian] or angustifolia [Indian senna], native to Northern Africa, middle East and India, similar constituents including anthraquinone glycosides, called sennosides).
Woolf GM. (1999). Senna-induced hepatotoxicity. Hepatology. (48 year old man developed jaundice 3 days after starting cascara sagrada [bilirubin 11.8 mg/dL, ALT 999 U/L, Alk P 309 U/L, ANA 1: 640] developing ascites, but recovering in 3 months).
Nadir A, Reddy D, Van Thiel DH. (2000). Cascara sagrada-induced intrahepatic cholestasis causing portal hypertension: case report and review of herbal hepatotoxicity. Am J Gastroenterol. (48 year old man developed jaundice 3 days after starting cascara sagrada [bilirubin 11.8 mg/dL, ALT 999 U/L, Alk P 309 U/L, ANA 1: 640], developing ascites, but recovering within 3 months of stopping).
Wurtz AS, Vial T, Isoard B, Saillard E. (2002). Possible hepatotoxicity from Copaltra, an herbal medicine. Ann Pharmacother. (49 year old woman developed jaundice 3 months after starting Copaltra tea [Coutarea latiflora and Centaurium erythreae] for diabetes [bilirubin 20.8 mg/dL, ALT 3010 U/L, Alk P 132 U/L], with recovery in 3 months).
De Smet PAGM. (2002). Herbal remedies. N Engl J Med. (Review of status and difficulties of herbal medications, including lack of standardization, federal regulation, contamination, safety, hepatotoxicity and drug-herb interactions; specific discussion of 4 herbs with therapeutic promise: ginkgo, hawthorn, saw palmetto and St. John’s wort).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury due to herbs, including discussion of potential risk factors, and herb-drug interactions; senna is listed as causing liver injury).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity; senna is not listed as causing hepatotoxicity).
Vashishtha VM. (2003). Brief profile of an epidemic of acute encephalopathy in Western Uttar Pradesh. Indian Pediatr. (Letter describing the course of 19 children living in Western Uttar Pradesh in India who had the sudden onset of fever and vomiting followed by abnormal behavior, agitation, stupor and coma with rise in serum ALT and AST and coagulopathy, but modest bilirubin elevations and normal cerebral spinal fluid examination and no evidence of measles or other acute exanthem; 16 [87%] died).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none attributed to senna).
Ernst E. (2004). Risks of herbal medicinal products. Pharmacoepidemiol Drug Saf. (Review of the adverse effects of over-the-counter herbal medications, focusing on the hepatotoxicity of kava, drug interactions with St. John’s wort, and contamination of traditional Chinese medications with heavy metals [arsenic, lead, mercury, thallium] and conventional western medications).
Seybold U, Landauer N, Hillebrand S, Goebel FD. (2004). Senna-induced hepatitis in a poor metabolizer. Ann Intern Med. (28 year old woman developed jaundice after drinking herbal tea containing senna leaves, with positive rechallenge [ALT ~1390 U/L, GGT ~190 U/L], with Rhein anthrone detectable in serum).
Vanderperren B, Rizzo M, Angenot L, Haufroid V, Jadoul M, Hantson P. (2005). Acute liver failure with renal impairment related to the abuse of senna anthraquinone glycosides. Ann Pharmacother. (52 year old woman developed jaundice, acute liver failure, lactic acidosis, and phosphate loosing nephropathy after ingesting herbal tea made from senna fruits for 3 years [bilirubin 6.2 mg/dL, ALT 9160 U/L, INR 5.3], requiring temporary ventilator support, ultimately resolving [Case 1]).
Sonmez A, Yilmaz MI, Mas R, Ozcan A, Celasun B, Dogru T, Taslipinar A, Kocar IH. (2005). Subacute cholestatic hepatitis likely related to the use of senna for chronic constipation. Acta Gastroenterol Belg. (77 year old male developed jaundice after taking a senna preparation for constipation for 3 months [bilirubin 4.9 rising to 16.9 mg/dL, ALT 657 U/L, Alk P 160 U/L], resolving within 1 month of stopping the herbal).
Vashishtha VM, Nayak NC, John TJ, Kumar A. (2007). Recurrent annual outbreaks of a hepato-myo-encephalopathy syndrome in children in western Uttar Pradesh, India. Indian J Med Res. (Characterization of clinical course of hepatomyoencephalopathy occurring in outbreaks among children in Uttar Pradesh, India marked by sudden onset of fever, vomiting, abnormal behavior followed by stupor, coma and death [in 76%] within 72 hours, typically with marked ALT and AST elevations, hypoglycemia, abnormal coagulation studies but modest bilirubin elevations; liver biopsies showing acute hepatotoxic injury, central necrosis and hydropic changes, muscle biopsies showing focal necrosis and brain histology showing mild spongiosis and focal gliosis).
Vashishtha VM, Kumar A, John TJ, Nayak NC. (2007). Cassia occidentalis poisoning causes fatal coma in children in western Uttar Pradesh. Indian Pediatr. (Home visits and family interviews of 10 Indian children with acute, severe hepatomyoencephalopathy found evidence that all 10 had consumed multiple Cassia occidentalis beans growing as weeds in their neighborhood shortly before becoming ill with liver injury, with stupor followed by coma and death [ALT 948-9160 U/L, CPK 42-4890 U/L, glucose <40 mg/dL in 6 of 10, prothrombin times abnormal in all]).
Bruguera M, Herrera S, Lazaro E, Madurga M, Navarro M, De Abajo FJ. (2007). Gastroenterol Hepatol. (Five cases of hepatotoxicity of Copalchi in 4 men and 1 woman ages 59 to 77 years, taking herb for 2-13 months [bilirubin 0.7-13 mg/dL, ALT 403-865 U/L, GGT 54-116 U/L], resolving after stopping in all 5).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry. Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, including one due to Cassia angustifolia [senna], with onset after 5 months [bilirubin 11.7 mg/dL, ALT 35 times ULN, Alk P 1.4 times ULN], resolving in one month).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but none were linked to senna or cascara).
Freeman HJ. (2008). "Melanosis" in the small and large intestine. World J Gastroenterol. (Pigment found in small and large intestine with long term anthracene laxative [cascara, senna, aloes and rhubarb], use is usually lipofuscin rather than hemosiderin or melanin and is present in macrophages in the lamina propria).
Soyuncu S, Cete Y, Nokay AE. (2008). Portal vein thrombosis related to Cassia angustifolia. Clin Toxicol (Phila). (42 year old woman developed abdominal pain and was found to have portal vein thrombosis 2 years after starting daily use of tea made from dried senna leaves [bilirubin normal, ALT 81 U/L]).
Jacobsen C, Semb S, Kromann-Andersen H. (2009). Ugeskr Laeger. (49 year old woman developed jaundice 4 weeks after starting daily ingestion of cascara sagrada for constipation [bilirubin 8.4 rising to 24.6 mg/dL, ALT 944 U/L, ascites], resolving within 4 months of stopping).
Vitalone A, Menniti-Ippolito F, Raschetti R, Renda F, Tartaglia L, Mazzanti G. (2012). Surveillance of suspected adverse reactions to herbal products used as laxatives. Eur J Clin Pharmacol. (Among 519 adverse events attributed to herbals reported to an Italian registry between 2002 and 2011, 26 were related to herbal laxatives, including 3 cases of liver injury, 1 due to cascara and 2 to senna).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, including three reports implicating senna: Beuers [1991], Seybold [2004], Vanderperen [2005]).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury mentions that senna has been associated with at least 3 published cases of liver injury).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, none of which were attributed to senna).
Nirupam N, Sharma R, Chhapola V, Kanwal SK, Kumar V. (2013). Hepatomyoencephalopathy due to Cassia occidentalis poisoning. Indian J Pediatr. (3 year old girl developed nausea, vomiting, excessive crying and self-mutilating behavior 3 days after eating Cassia orientalis beans growing in her neighborhood [bilirubin 1.9 mg/dL, ALT 3310 U/L, Alk P 1331 U/L, INR 2.7, ammonia 275 µg/L, CPK 1226 U/L], recovering with medical support after 8 days).
Panigrahi G, Tiwari S, Ansari KM, Chaturvedi RK, Khanna VK, Chaudhari BP, Vashistha VM, et al. (2014). Association between children death and consumption of Cassia occidentalis seeds: clinical and experimental investigations. Food Chem Toxicol. (Injury similar to that in hepato-myo-encephopathy was produced in rodents using extracts of seeds of Cassia occidentalis with 2- to 3-fold increase in serum ALT levels, marked hypoglycemia and hepatic centrozonal necrosis).
Teschke R, Genthner A, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2014). Herbal hepatotoxicity: Analysis of cases with initially reported positive re-exposure tests. Dig Liver Dis. (Reanalysis of 34 published cases of liver injury due to herbal medications in which there was a reported positive rechallenge, finding only 21 [62%] fulfilled the criteria of a positive rechallenge using RUCAM, the others having inconsistent [18%] or incomplete data [21%]; among those with a confirmed positive rechallenge was one case due to senna [Beuers 1991]).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to senna).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver does not discuss senna or cascara).
Izzy M, Malieckal A, Little E, Anand S. (2016). Review of efficacy and safety of laxatives use in geriatrics. World J Gastrointest Pharmacol Ther. (Systematic review of 9 randomized controlled trials of laxatives in geriatric patients suggested that senna was the preferred agent in the elderly in regards to efficacy and safety; no mention of hepatotoxicity or restriction in the duration of therapy).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products, but does not list or mention cases attributed to senna).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists 4 reports of liver injury attributed to senna).
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al., Drug Induced Liver Injury Network (DILIN). (2017). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the State of Delaware. Drug Saf. (A prospective, population based registry of cases of drug induced liver injury occurring in Delaware during 2014, identified 20 cases [2.7 per 100,000] overall, including 6 due to HDS products, all of which were proprietary multiingredient products, none specifically listing senna as a component).
Alsalimy N, Madi L, Awaisu A. (2018). Efficacy and safety of laxatives for chronic constipation in long-term care settings: A systematic review. J Clin Pharm Ther. (Systematic review of 7 controlled trials of laxatives in 444 adults with chronic constipation found all agents equally effective and with no serious adverse events, common side effects being gastrointestinal discomfort, flatulence and diarrhea).
Vilanova-Sanchez A, Gasior AC, Toocheck N, Weaver L, Wood RJ, Reck CA, Wagner A, et al. (2018). Are Senna based laxatives safe when used as long term treatment for constipation in children?. J Pediatr Surg. (Among 640 children with chronic constipation treated with senna long term, 16 had side effects, most commonly abdominal pain and cramps or diarrhea, typically during the first few weeks of treatment, resolving spontaneously or with changing laxatives; 2% of children developed perineal rash or blisters, all with diarrhea and diaper use due to exposure to stool; no instances of liver injury reported).
Chhapola V, Kanwal SK, Sharma AG, Kumar V. (2018). Hepatomyoencephalopathy secondary to Cassia occidentalis poisoning: report of three cases from North India. Indian J Crit Care Med. (Clinical course of 3 children with hepatomyoencephalopathy due to ingestion of Cassia Occidentalis seeds with fever, vomiting and stupor [bilirubin 2.8 to 5.1 mg/dL, ALT 1749 to 3310 U/L, Alk P 369 to 1331 U/L, INR 1.74 to 3.95], all receiving supportive care and surviving, but all 3 had a sibling who had recently died of a similar syndrome at home).
Ish P, Rathi S, Singh H, Anuradha S. (2019). Senna Occidentalis poisoning: an uncommon cause of liver failure. ACG Case Rep J. (75 year old woman developed liver injury after 2 weeks of self-medication with Cassia occidentalis for osteoarthritis [bilirubin 0.8 rising to 18.7 mg/dL, ALT 42 rising to 542 U/L, Alk P 105 rising to 184 U/L, ammonia 127 µg/L, INR 1.28], dying of intractable status epilepticus and liver biopsy showing massive necrosis [Case 2]).

## OTHER REFERENCE LINKS

1 Recent References on Senna: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=senna+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Senna: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=senna)